# Tobramycin

## OVERVIEW

### Introduction

Tobramycin is a parenterally administered, broad spectrum aminoglycoside antibiotic that is widely used in the treatment of moderate to severe bacterial infections due to sensitive organisms. Despite its wide use, tobramycin has rarely been linked to instances of clinically apparent liver injury.

### Background

Tobramycin (toe" bra mye' sin) is a semisynthetic aminoglycoside, similar in spectrum of activity to gentamicin, that is widely used for severe bacterial infections caused by sensitive agents, primarily aerobic gram negative bacteria. Like other aminoglycosides, tobramycin is thought to act by binding to bacterial ribosomes and inhibiting protein synthesis. Nevertheless, tobramycin is considered bacteriocidal as well as bacteriostatic. Tobramycin and other aminoglycosides are typically used in combination with a penicillin or cephalosporin for treatment of severe infections with E. coli, Staphylococcus aureus, Enterobacter, Klebsiella, Serratia, Pseudomonas aeruginosa, and other gram negative bacteria resistant to less toxic antibiotics. Tobramycin is most commonly used for septicemia, bacterial endocarditis, peritonitis, meningitis, pelvic inflammatory disease and pneumonia. Tobramycin was approved for use in the United States in 1980 and is available in multiple generic forms in parenteral formulations; typical adult doses are 3 mg/kg per day im or iv, usually in three divided doses, often after an initial loading dose. The dose of tobramycin must be modified based upon renal function and monitoring of drug levels is advisable. Pediatric formulations, nebulizer solutions for inhalation, and topical formulations for ophthalmologic use are also available. Common side effects include dizziness, headache, confusion, nausea and skin rash. Important, dose related adverse effects include oto- and nephrotoxicity, which are shared by all aminoglycosides.

### Hepatotoxicity

Intravenous and intramuscular therapy with tobramycin is usually associated with no increase in rates of serum aminotransferase or bilirubin elevations. Only isolated case reports of acute liver injury with jaundice have been associated with aminoglycoside therapy including tobramycin, not all of which are very convincing. The hepatic injury is typically mixed but can evolve into a cholestatic hepatitis. The latency to onset is rapid, occurring within 1 to 3 weeks and is typically associated with skin rash, fever and sometimes eosinophilia. Recovery typically occurs within 1 to 2 months and chronic injury has not been described. Aminoglycosides are not mentioned in large case series of drug induced liver disease and acute liver failure; thus, hepatic injury due to tobramycin is rare if it occurs at all.

### Mechanism of Injury

The cause of symptomatic, icteric hepatic injury from tobramycin is not known, but is likely to be immunoallergic. Uptake of the aminoglycosides into hepatocytes is limited and they are rapidly excreted in the urine; high concentrations are found mainly in renal tubular cells and hair cells of the inner ear, perhaps explaining why they are more likely to cause nephro- or oto- rather than hepatotoxicity.

### Outcome and Management

The outcome of hepatic injury due to aminoglycosides is usually benign. Acute liver failure has not been associated with tobramycin use and no convincing cases of chronic bile duct vanishing syndrome have been described after its use. Patients with tobramycin hepatotoxicity should probably avoid all systemic aminoglycoside use.

References to the safety and potential hepatotoxicity of tobramycin are provided in the Overview section on the Aminoglycosides.

Drug Class: Aminoglycosides

Other Drugs in the Class: Amikacin, Gentamicin, Neomycin, Plazomicin, Streptomycin

## CASE REPORT

### Case 1. Acute hepatitis arising during tobramycin therapy.

[Modified from: Nisly SA, Ray SM, Moye RA. Tobramycin-induced hepatotoxicity. Ann Pharmacother 2007; 41: 2061-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/17956959)]

A 20 year old woman with osteomyelitis was treated with intravenous tobramycin and ceftazidime and developed rising levels of ALT and AST with mild jaundice. The patient had a past history of surgery on her right femur and recurrent osteomyelitis. She presented with fever and chills and was started on intravenous piperacillin/tazobactam, ciprofloxacin and vancomycin, which was changed to intravenous ceftazidime and tobramycin when blood cultures revealed P. aeruginosa, sensitive to this regimen. Serum ALT, AST and Alk P levels started to rise (see Table), and piperacillin/tazobactam was substituted for ceftazidime. Tests for hepatitis A, B and C were negative. Imaging showed no evidence of gallstones or biliary obstruction. Because of further increases in liver tests, aztreonam was substituted for piperacillin/tazobactam. When serum bilirubin began to rise, all antibiotics were stopped. Thereafter, liver tests began to improve, and they continued downward even with reinitiation of intravenous aztreonam and ciprofloxacin. Serum aminotransferase levels were near normal by the time of discharge.

#### Key Points

Medication: | Tobramycin, 70-100 mg every 8 hours for 9 days
Pattern: | Mixed (R=~3)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3-4 days to ALT elevations, 8 days to jaundice
Recovery: | One week
Other medications: | Paroxetine, alprazolam, hydrocodone/acetaminophen, oxycodone, hydromorphone, promethazine, docusate, metoclopramide, piperacillin/tazobactam, ciprofloxacin, aztreonam, and ceftazidime

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 48 | 220 | 3.2 | Admission with fever
1 day | | 40 | 200 | | Started tobramycin/ceftazidime
6 days | | 139 | 432 | 1.8 | Piperacillin/tazobactam started
8 days | | 315 | 330 | 4.9 | Aztreonam started
10 days | | 330 | 320 | | All antibiotics stopped
12 days | 0 | 210 | 225
13 days | 1 days | 180 | 210
14 days | 2 days | 160 | 200 | | Aztreonam/ciprofloxacin started
15 days | 3 days | 110 | 180
17 days | 5 days | 65 | 158 | 1.5
Normal Values | | <55 | <148 | <1.2

#### Comment

While the timing of onset and subsequent improvement in serum aminotransferase and alkaline phosphatase levels suggest that tobramycin might be the cause of the liver injury, the history is complex. The patient was mildly jaundiced and had evidence for underlying liver disease at the time of admission before antibiotic therapy (this may have been due to sepsis). Furthermore, she received a multitude of medications, including several other antibiotics that are capable of causing liver injury (piperacillin, ciprofloxacin, ceftazidime). Because of the polypharmacy and presence of sepsis, the likelihood that the injury was due to tobramycin might be rated as only possible.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tobramycin – Generic

DRUG CLASS

Aminoglycosides

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tobramycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tobramycin | 32986-56-4 | C18-H37-N5-O9 | Tobramycin chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Tobramycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=tobramycin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tobramycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=tobramycin)